# Naloxone

## OVERVIEW

### Introduction

Naloxone is an opiate antagonist which is used intravenously in emergency situations to reverse the respiratory depression caused by overdoses of heroin, morphine or other opioids. Naloxone has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Naloxone (nal ox’ one) is a derivative of the natural plant alkaloid thebaine and is similar to oxymorphone. Naloxone, however, is a competitive antagonist of the opiate receptors and has particularly high affinity for the μ opiate receptor and can displace morphine and other full agonists, thereby reversing their effects. Naloxone causes rapid onset of withdrawal symptoms in opioid dependent persons and is generally used in emergency rooms to treat the respiratory depression caused by opioid overdose or postoperatively to reverse opioid anesthetic effects. Naloxone has sometimes been provided to emergency medical personnel and police and fire personnel for use onsite in emergency situations. Naloxone was first approved for use in the United States in 1971. It remains available as a solution for injection in generic forms and under the brand name Narcan, typically in concentrations of 0.4 mg/mL to be given intramuscularly or intravenously. It is also available as a nasal spray in solution of 4 mg/0.1mL. The usual initial dose in adults with suspected opioid overdose is 0.4 to 2.0 mg. Naloxone is also available in fixed combination with buprenorphine for sublingual use (Suboxone and generic) and with pentazocine for oral use. Naloxone is poorly absorbed by the sublingual or oral route and is added to discourage the intravenous or parenteral administration of buprenorphine or pentazocine. Side effects of naloxone in opioid dependent persons include mood changes, sweating, anxiety, restlessness, trembling, dizziness, flushing, headache, nausea, vomiting, cardiac tachyarrhythmias, seizures, chest pain and acute pulmonary edema—symptoms of acute opioid withdrawal. Naloxone has minimal effects in persons not taking opioids. Naloxone is not a controlled substance, but its use is sometimes restricted to medical staff trained in emergency medicine or anesthesia.

### Hepatotoxicity

Therapy with naloxone has not been linked to serum enzyme elevations or to idiosyncratic acute, clinically apparent liver injury. Patients with opioid overdose often have underlying chronic liver diseases such as alcoholic liver disease, hepatitis B or C, but treatment with naloxone does not appear to exacerbate those conditions. Naloxone is extensively metabolized in the liver, but largely by conjugation with glucuronide followed by its urinary excretion.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Opioid Antagonists; see also Substance Abuse Treatment Agents

Other Drugs in the Class: Nalmefene; Naloxegol, Naltrexone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Naloxone – Generic, Narcan®

DRUG CLASS

Opioid Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=NARCAN&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Naloxone | 357-08-4 | C19-H21-N-O4.Cl-H

## ANNOTATED BIBLIOGRAPHY

References updated: 24 March 2020

Zimmerman HJ. Narcotic analgesics. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 710-11. (Expert review of hepatotoxicity published in 1999; mentions that trials of naltrexone have reported serum aminotransferase elevations in up to 30% of recipients, an effect that appeared to be partially dose dependent; naloxone not discussed).
Larrey D, Ripault MP. Illegal and recreational compounds. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 456-7. (Review of hepatotoxicity discusses buprenorphine, an orally available morphine analogue, which has been linked to cases of severe acute liver injury, usually as a result of intravenous administration; naloxone not discussed).
Yaksh TL, Wallace MS. Opioids, analgesia, and pain management. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 355-86. (Textbook of pharmacology and therapeutics).
Wiesen RL, Rich CR, Wang RI, Stockdale SL. (1977). The safety and value of naloxone as a therapeutic aid. Drug Alcohol Depend. (Among 343 subjects with suspected opioid dependence given intravenous naloxone to assess the presence and degree of dependence, no patient developed a serious adverse event; no mention of liver injury or ALT levels).
Bracken MB, Shepard MJ, Collins WF, Holford TR, Young W, Baskin DS, Eisenberg HM, et al. (1990). A randomized, controlled trial of methylprednisolone or naloxone in the treatment of acute spinal-cord injury. Results of the Second National Acute Spinal Cord Injury Study. N Engl J Med. (Among 487 patients with acute spinal cord injury treated with intravenous, high dose methylprednisolone, naloxone or placebo, side effects and complications were comparable among the three arms; no mention of ALT elevations or hepatotoxicity).
Olinger CP, Adams HP, Brott TG, Biller J, Barsan WG, Toffol GJ, Eberle RW, et al. (1990). High-dose intravenous naloxone for the treatment of acute ischemic stroke. Stroke. (Among 38 patients with acute ischemic stroke given a 24 hr infusion of naloxone, side effects included nausea, vomiting, hypotension, focal seizures, and mild bilirubin elevations [peak 1.7 mg/dL], which rapidly returned to normal; no mention of ALT elevations or hepatotoxicity).
Kaplan JL, Marx JA, Calabro JJ, Gin-Shaw SL, Spiller JD, Spivey WL, Gaddis GM, Zhao N, Harchelroad FP. (1999). Double-blind, randomized study of nalmefene and naloxone in emergency department patients with suspected narcotic overdose. Ann Emerg Med. (Controlled trial of two doses of nalmefene vs naloxone in 118 patients with suspected opioid overdose found similar rates of response and no serious adverse events).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none to nalmefene, naltrexone or other agents used to treated substance abuse).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to naloxone or other opioid antagonist).
Lucas GM, Young A, Donnell D, Richardson P, Aramrattana A, Shao Y, Ruan Y, et al., HPTN 058 study group. (2014). Hepatotoxicity in a 52-week randomized trial of short-term versus long-term treatment with buprenorphine/naloxone in HIV-negative injection opioid users in China and Thailand. Drug Alcohol Depend. (Among 1036 patients with opioid dependency treated with buprenorphine/naloxone short term (18 days) or long term [1 year], mean ALT levels and proportion with ALT elevations were similar in the two groups at 3, 6, 9 and 12 months).
Soyka M, Backmund M, Schmidt P, Apelt S. (2014). Buprenorphine-naloxone treatment in opioid dependence and risk of liver enzyme elevation: results from a 12-month observational study. Am J Addict. (Among 181 patients with opioid dependency started on buprenorphine-naloxone and treated for at least 12 months, 3 to 7 had ALT elevations during visits at 3, 6, and 12 months [range 51 to 91 U/L], but all were less than 3 times ULN, and no patient developed clinically apparent liver injury or required drug discontinuation for liver test abnormalities).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to naloxone or other opioid antagonist).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to naloxone or other opioid antagonist).
Chaignot C, Zureik M, Rey G, Dray-Spira R, Coste J, Weill A. (2018). Risk of hospitalisation and death related to baclofen for alcohol use disorders: Comparison with nalmefene, acamprosate, and naltrexone in a cohort study of 165 334 patients between 2009 and 2015 in France. Pharmacoepidemiol Drug Saf. (Analysis of the French Health Insurance claims database of patients initiating alcohol use disorder therapies found an increased risk of hospitalization [+13%] and death [+31%] compared to exposure to approved drugs such as acamprosate, naltrexone and nalmefene).
(2018). Opioids for pain. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of opioids used for pain mentions that the 3 opioid antagonists that are used to treat opioid induced constipation-methylnaltrexone, naloxegol and nalmedine-have similar degrees of efficacy and toxicities).

## OTHER REFERENCE LINKS

1 Recent References on Naloxone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Naloxone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Naloxone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Naloxone)